# Acute Hepatic Necrosis

Description. The clinical course of acute hepatic necrosis resembles an acute, toxic injury to the liver with sudden and precipitous onset, marked elevations in serum aminotransferase levels, and early signs of hepatic (or other organ) dysfunction or failure despite minimal or no jaundice. Rapid recovery after withdrawal of the agent is also typical. Other organ failure, such as lung, kidney or bone marrow, may also be present and may overshadow the hepatic injury. Acute hepatic necrosis is typically caused by a direct hepatotoxin and is usually dose dependent and “expected”, rather than idiosyncratic.

Latency to Onset. The time to onset of acute hepatic necrosis is typically short, 1 to 14 days.

Symptoms. Usually abrupt onset of nausea, weakness, fatigue and abdominal pain; somnolence and mental clouding may occur early. Itching is rare and jaundice appears later. Other organ failure (kidney, lung, bone marrow) may be prominent.

Serum Enzyme Elevations. ALT rising rapidly to above 800 IU/L (>20 times ULN), with alkaline phosphatase <2 times ULN (<230 U/L). As a result, the R ratio (ALT divided by Alk P, both expressed as multiples of the upper limit of normal) tends to be very high (>10). If measured, LDH levels are also elevated. Serum creatinine, BUN, INR and ammonia are also often raised, sometimes before hyperbilirubinemia (which is usually mild to moderate even at the height). Strikingly, the serum enzymes usually improve rapidly with stopping the medication, falling by 50% within 8 days.

Drugs. Typical causative agents include acetaminophen, aspirin, cocaine, niacin, high dose intravenous amiodarone, methotrexate, terbutaline, and direct toxins such as phosphorus or penny royal oil. In some instances, the hepatic injury is not a direct effect of the drug on the liver, but an indirect effect due to ischemic hepatic necrosis caused by sudden and severe heart failure, hypotension, shock, hyperthermia, or hypoxia.

Differential Diagnosis. The major diagnoses that should be excluded include ischemic hepatitis due to hypotension, hypoxia, or heat stroke. The episode of shock or hypoxia may have been unnoticed or poorly documented, even in the setting of inhospital observation. Ischemic hepatitis should be particularly suspected in patients with heart failure, arrhythmias, severe asthma or pulmonary disease, and status epilepticus. In some instances, the ischemic hepatitis is “drug induced”, such as after general anesthesia or propofol.

Criteria for Definition. Elements important in diagnosis of acute hepatic necrosis include:

1 Latency of less than 14 days
2 Abrupt onset of symptoms
3 Alanine aminotransferase (ALT) levels above 800 U/L (>20 times ULN)
4 Alkaline phosphatase (Alk P) levels that are normal or only modestly elevated (<2 times ULN).
5 Bilirubin <10 mg/dL at time of diagnosis
6 Acute injury and dysfunction of other organ systems (lungs, kidneys, bone marrow)
7 If liver biopsy is obtained, changes of acute zone 3 coagulative necrosis with scant lobular lymphocytic infiltration, little or no fibrosis or cholestasis and no veno-occlusive changes.

A case might be considered “probable” if typical features are found, but ALT levels rise to only 400 to 800 U/L (between 10 and 20 times ULN). There may be some overlap between acute hepatic necrosis and drug induced acute hepatitis, but latency and recovery are typically longer with acute hepatitis. Acute hepatic necrosis can cause acute liver or multiorgan failure. Immunoallergic features (rash, fever, eosinophilia) may be present, but are usually not prominent. Autoantibodies are absent. Cirrhosis following acute hepatic necrosis is very rare, but isolated instances of residual inactive cirrhosis or advanced fibrosis have been reported.

## Representative Cases

### Case 1. Acute hepatic necrosis with jaundice due to high doses of niacin.

[Modified from: Patterson DJ, Dew EW, Gyorkey F, Graham DY. Niacin hepatitis. South Med J 1983; 76: 239-41. PubMed Citation]

A 41 year old man with history of taking 4.5 grams of niacin daily for 5 months presented with nausea, anorexia, weakness and abdominal pain followed by jaundice. He was icteric, but had no fever or rash. Blood tests showed marked elevations in serum aminotransferase levels and jaundice (Table). Tests for hepatitis B and autoantibodies were negative. An initial prothrombin time was 28.5 seconds (normal <14 seconds), but it corrected within 3 days of stopping niacin. A liver biopsy showed submassive lobular collapse, marked cholestasis, ballooned hepatocytes and mild fibrosis. Once niacin was stopped, he improved rapidly and serum enzymes fell to normal within a month. Review of this history revealed that he had developed jaundice while taking niacin in the past, had recovered on stopping, but nevertheless began taking it again.

#### Key Points

Medication: | Niacin 4.5 grams daily
Pattern: | Hepatocellular (R=24)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 months
Recovery: | 4 days for symptoms, 49 days for ALT
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Niacin started, increasing to 4.5 grams/day
20 weeks | | Admission: niacin stopped | | | Nausea, vomiting and jaundice
20 weeks | 0 | 3300 | 379 | 7.2 | Protime 28.5 sec
| 2 days | 2155 | 343 | 8.0
| 4 days | 1212 | 299 | 6.6 | Protime 12.5 sec
21 weeks | 9 days | 237 | 193 | 2.2 | Discharged
27 weeks | 7 weeks | 35 | 78 | 0.7
30 weeks | 10 weeks | 26 | 57 | 0.3
Normal Values | | <41 | <115 | <1.2

#### Comment

A typical example of hepatotoxicity from high doses of niacin. The latency probably related to the gradual increase in dose of niacin and the hepatic injury triggered by reaching toxic levels. Serum aminotransferases were markedly elevated, and there was a prompt improvement with stopping therapy, levels falling by more than 50% within 3 days. The cellular injury in acute hepatic necrosis is more typical of “necrosis” as opposed to “apoptosis”, which is the major form of hepatocellular injury in viral hepatitis. The prolongation of the prothrombin time indicated the severity of the injury and biopsy showed submassive necrosis and collapse. Multiple such episodes might lead to posthepatic cirrhosis.

### Case 2. Acute hepatic necrosis from high dose intravenous amiodarone therapy.

[Modified from patient 1 in: Pye E, Northcote RJ, Cobbe SM. Acute hepatitis after parenteral amiodarone administration. Br Heart J 1988; 59: 690-1. PubMed Citation]

A 48 year old woman with valvular heart disease and atrial fibrillation was treated with intravenous amiodarone and developed acute elevations in serum aminotransferase levels and mild jaundice that reversed rapidly. She had undergone both mitral and aortic valve replacement in the past and had chronic congestive heart failure that was worsened by the onset of rapid atrial fibrillation. After several days of monitoring, she was given amiodarone using a bolus dose of 300 mg and then 900 mg daily. Discontinuation of amiodarone was followed by rapid fall of serum aminotransferase levels to pretreatment values.

#### Key Points

Medication: | Amiodarone
Pattern: | Hepatocellular (R=13.1)
Severity: | 3+ (ALT elevations with jaundice and prolongation of hospitalization)
Latency: | 1 day
Recovery: | One to two weeks
Other medications: | Digoxin, verapamil, others not given

#### Laboratory Values

Time After Starting | Time After Stopping | ALT ( U/L) | Alk P (U/L) | | Bilirubin* (mg/dL) | Other
-3 days | | 45 | 145 | | 2.0
-1 days | | 22 | 150 | | 1.8
0 | | 28 | 185 | | 1.8 | Amiodarone started
1 day | | 580 | 150 | | 3.8
2 days | 0 | 1770 | 140 | | 9.1 | Amiodarone stopped
3 days | 1 day | 1450 | 140 | | 8.5
4 days | 2 days | 740 | 160 | | 5.9
5 days | 3 days | 700 | 156 | | 4.7
1 week | 5 days | 320 | 170 | | 3.2
2 weeks | 10 days | 50 | 120 | | 1.5
Normal Values | | <55 | <280 | | <1.2

* Converted from μmol.

#### Comment

The patient experienced a marked rise in serum aminotransferase levels and jaundice within a day of starting intravenous amiodarone for atrial fibrillation. This patient probably had underlying congestive liver disease from chronic right heart failure as shown by the slight elevations in bilirubin and ALT levels before amiodarone therapy. Thus, amiodarone acute hepatic injury may occur predominantly in patients with an underlying degree of liver injury from heart failure and ischemia. The form of injury is acute hepatic necrosis with rapid rise and rapid fall in enzyme levels.

### Case 3. Acute hepatic necrosis after methylenedioxymetamphetamine (Ecstasy) use.

[Modified from: Brown C, Osterloh J. Multiple severe complications from recreational ingestion of MDMA ('Ecstasy'). JAMA 1987; 258: 780-1. PubMed Citation]

A 32 year old woman developed hallucinations and confusion a few hours after ingesting 100 to 150 mg of methylenedioxymetamphetamine (MDMA) and was brought to the emergency room with agitation, disorientation and high fever. On examination, she had tachycardia (150/min), hypotension (90/50 mm Hg), tachypnea (36/min) and fever (41.6 oC). She had dilated pupils, nystagmus and hyperreflexia. Laboratory tests showed normal blood counts and liver tests with mild dehydration (creatinine 1.9 mg/dL), and serious hypoxemia (pO2 44 mm). She was admitted to an intensive care unit for ventilator support for 24 hours. Thereafter, she had weakness, anorexia and nausea, but improved over the next week and was discharged 10 days after admission. She had no previous history of liver disease or jaundice and took no other medications. She had used MDMA previously without complications. She denied injection drug use. During the course of her hospitalization, she developed elevations in serum enzymes and jaundice (Table). The prothrombin time became abnormal, but she remained stable and liver test abnormalities were markedly improved over the 10 day hospitalization. Analysis of the recovered powder that was taken demonstrated that it was 99% pure MDMA.

#### Key Points

Medication: | Methylenedioxymetamphetamine (MDMA: "Ecstasy”)
Pattern: | Hepatocellular (R=~100)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 days to jaundice
Recovery: | Rapid, not completely documented
Other medications: | None mentioned

#### Laboratory Values

Time After Stopping | AST (U/L) | Alk P (U/L) | Protime (seconds) | Bilirubin (mg/dL) | Other
| | Single ingestion of MDMA
0 | 30 | 50 | 13.6 | 0.4 | Admission
1 day | 385 | 65 | 33.2 | 1.2 | Extubation
2 days | | | 37.9
3 days | 1820 | 107 | 18.9 | 6.8
4 days | 1435 | 90 | 13.8 | 7.6
5 days | 1680 | 145 | 12.8 | 5.6
10 days | 237 | 68 | | 1.6
Normal Values | <42 | <115 | <14.5 | <1.2

#### Comment

Abuse of MDMA, an amphetamine derivative used orally as a “social” drug, often during “rave” parties, has been associated with severe toxic reactions with severe hyperthermia, shock, respiratory failure and hepatitis. This case demonstrates “hyperacute” hepatic failure that can occur with MDMA use. The liver injury arises 1 to 3 days after the initial presentation with hyperthermia, hypotension and hypoxia, the prothrombin time becoming abnormal immediately followed by rise in ALT and AST and jaundice. The clinical pattern is “acute hepatic necrosis” as occurs with toxic reactions, most typically with acetaminophen overdose. The cause of the hyperacute hepatic failure due to MDMA may actually be the effects of hypotension, hypoxia and hyperthermia on the liver, as the early hepatic histology resembles hyperthermia induced liver injury (fat accumulation and central coagulative necrosis). Why a person who has been regularly abusing MDMA should suddenly have such an overwhelming toxic reaction is unclear, but it probably represents drug overdose and administration of more than claimed dose of the illegally (and unreliably) prepared substance or else an underlying change in susceptibility (perhaps dehydration from participation in a “rave” or a concurrent illness).

### Case 4. Severe acute acetaminophen hepatotoxicity after an intentional overdose.

[Acute Liver Failure Study Group Patient #2281]

A 27 year old woman took an overdose of acetaminophen (30 tablets of 325 mg each) in a suicide attempt, because of a failed romantic relationship. The following day she was nauseated and vomited several times, but she waited another day before presenting to an emergency room, approximately 48 hours after the ingestion. She had no other significant medical problems and denied a history of liver disease, alcohol abuse or risk factors for viral hepatitis. On presentation, she was oriented but drowsy. Her vital signs included pulse of 125/min, BP 100/65, respirations 25/min and temperature 37 °C. She was mildly jaundiced, but had no rash or signs of chronic liver disease. The total serum bilirubin level was 4.4 mg/dL, ALT 3,570 U/L, AST 7,377 U/L, and alkaline phosphatase 109 U/L (Table). A urine toxicology screen was positive for benzodiazepines and cocaine. Serum acetaminophen level was 31 mcg/mL, and serum acetaminophen adducts were positive (23.8 nmol/mL). She was admitted to the intensive care unit and given intravenous N-acetylcysteine. Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction. Over the next few days she had mild hepatic encephalopathy. She was placed on a liver transplantation waiting list, but began to improve spontaneously, and was transferred to a psychiatric service after a week in the hospital. When finally discharged several weeks later, all liver tests had returned to normal.

#### Key Points

Medication: | Acetaminophen (~10 grams as a single overdose)
Pattern: | Hepatocellular (R=~100)
Severity: | Severe (jaundice, encephalopathy and INR prolongation)
Latency: | 2 days
Recovery: | ~2 weeks
Other medications: | Possibly cocaine and benzodiazepines

#### Laboratory Values

Time After Ingestion | ALT (U/L) | Bilirubin (mg/dL) | INR | Other
2 days | 3570 | 4.4 | 6.9 | Admission
3 days | 7372 | 4.2 | 6.6 | Encephalopathy
4 days | 5139 | 4.7 | 4.0
5 days | 2852 | 5.6 | 3.7
6 days | 1764 | 6.3 | 3.0
7 days | 1478 | 8.0 | 3.2
8 days | 828 | 9.9 | 2.1 | Transferred from ICU
2 weeks | Normal | Normal | Normal | Discharged
Normal Values | <42 | <1.2 | <1.2

#### Comment

Acetaminophen hepatotoxicity typically presents within 2 to 5 days of an intentional overdose with a pattern of acute hepatocellular necrosis with striking elevations of aminotransferase levels (often above 2000 U/L and higher than typically seen with acute viral hepatitis). Jaundice typically worsens over the first few days, while signs of hepatic failure may improve (encephalopathy and coagulopathy). Patients may also have renal insufficiency. This is the classical pattern of acute hepatic necrosis and is typically the result of exposure to a direct toxin rather than an idiosyncratic reaction to a medication. Late presentation (>48 hours) after a suicidal overdose is associated with severe toxicity while early presentation (<12 to 24 hours) is associated with milder degrees or no liver injury provided the antidote, N-acetylcysteine, is given promptly on arrival.

## Hepatic Histology of Acute Hepatic Necrosis

Pure cases of acute hepatic necrosis (those without preexisting liver disease) have a simple histological appearance. There is zonal coagulative necrosis that may vary in intensity from involvement of a fraction of one acinar zone to necrosis of the entire acinus. Early in the injury, hepatocyte ghost cells will be seen in the areas of necrosis, but if the patient survives the initial insult, neutrophils and macrophages will begin to migrate in to the necrotic zone, beginning at the edges. Eventually all of the necrotic hepatocytes will be removed, leaving behind an area of necrotic collapse filled with pigmented macrophages. This process will begin within 12 to 24 hours of injury and may be completely resolved within one to two weeks, depending on the degree of necrosis. At the edges of the necrotic zone, hepatocyte apoptosis may be seen. The remaining hepatocytes may show steatosis. This latter finding is characteristic of acetaminophen injury as well as other causes of acute hepatic necrosis. Zone 3 is usually the zone affected, but zone 1 coagulative necrosis occurs with some types of direct hepatotoxins. There is usually little lymphocytic infiltrate associated with the necrosis and the presence of significant inflammation should suggest other patterns of liver injury.

The histological differential diagnosis mainly consists of causes of hypoxic-ischemic injury. Such injury may be seen secondary to shock from any cause as well as from sinusoidal obstruction syndrome (SOS). Some forms of SOS will have little inflammation and prominent zone 3 coagulative necrosis, mimicking the pattern of acute hepatic necrosis. The central veins should be carefully inspected for the characteristic veno-occlusive lesions. Zone 3 necrosis may be seen as a component of acute or chronic hepatitis, particularly hepatitis due to autoimmune hepatitis. In such cases, there will be significant inflammatory infiltrate in the necrotic areas, often with plasma cells or eosinophils.

## Histologic Images

Photomicrographs

David E. Kleiner, MD, PhD

Laboratory of Pathology

National Cancer Institute

Case A. Acetaminophen Toxicity

Photomicrographs from an explant, probably from a child.

Case contributed by Dr. Linda Ferrell, UCSF, Department of Pathology.

Histologic Features to Note:

Acute Hepatic Necrosis – Case A – At low magnification there is zonal necrosis present, seen as areas of darker pink (arrows) against the viable hepatocytes which are pale due to steatosis and ballooning injury.

Case A. Acetaminophen Toxicity. Photomicrographs from an explant, probably from a child.

Case A. Acetaminophen Toxicity

Histologic Features to Note:

Acute Hepatic Necrosis – Case A – Here the zonal necrosis is present around three central veins (V), while hepatocytes near portal areas (P) remain viable.

Case A. Acetaminophen Toxicity. Acute Hepatic Necrosis

Case A. Acetaminophen Toxicity

Histologic Features to Note:

Acute Hepatic Necrosis – Case A – A few viable hepatocytes are left near the vein, but most are present as hepatocyte ghosts. Macrophages (arrows) have infiltrated into the necrotic zone. Hepatocytes around the edges of the necrosis show ballooning injury and steatosis.

iCase A. Acetaminophen Toxicity. Acute Hepatic Necrosis.

Case A. Acetaminophen Toxicity

Histologic Features to Note:

Acute Hepatic Necrosis – Case A – The hepatocytes near the portal area are viable, but show ballooning injury and steatosis. There is no inflammation.

Case A. Acetaminophen Toxicity. Acute Hepatic Necrosis.

Case B. Acetaminophen Toxicity

This section is also from an explant, probably from an adult. The history included alcohol abuse, which may account for the striking degree of steatosis as well as the inflammation in some of the portal areas.

Case contributed by Dr. Linda Ferrell, UCSF Department of Pathology.

Histologic Features to Note:

Acute Hepatic Necrosis – Case B – At low magnification there is marked steatosis involving zones 2 and 3, but the coagulative necrosis is not yet evident. There is some inflammation, seen here as patches of purple cells (arrows) in the portal areas.

Case B. Acetaminophen Toxicity. This section is also from an explant, probably from an adult.

Case B. Acetaminophen Toxicity

Histologic Features to Note:

Acute Hepatic Necrosis – Case B – In zone 3, many of the hepatocytes are necrotic and some lipid vacuoles have merges to form lipid lakes. Most of the nuclei that can be seen belong to sinusoidal cells such as endothelial cells and macrophages.

Case B. Acetaminophen Toxicity. Acute Hepatic Necrosis

Case B. Acetaminophen Toxicity

Histologic Features to Note:

Acute Hepatic Necrosis – Case B – The portal areas show inflammation, most likely related to preexisting alcoholic liver disease. The hepatocytes are mostly viable, but an edge the necrotic zone is apparent (arrows).

Case B. Acetaminophen Toxicity. Acute Hepatic Necrosis